# Viltolarsen

## OVERVIEW

### Introduction

Viltolarsen is a synthetic antisense oligonucleotide designed to cause skipping of abnormal exons in the synthesis of the dystrophin gene and that is used to treat Duchenne muscular dystrophy. Viltolarsen has not been reported to cause ALT elevations during therapy and has not been linked to instances of acute liver injury with symptoms and jaundice.

### Background

Viltolarsen (vil” toe lar’ sen) is a synthetic antisense oligonucleotide designed to cause exon 53 skipping during the processing of the mRNA of the dystrophin gene, which encodes an essential protein for muscle integrity and is mutated in Duchenne muscular dystrophy. Patients with Duchenne muscular dystrophy typically have deletion mutations in exons [43 to 55], which disrupt the open-reading frame and the normal synthesis of dystrophin. The lack of functional dystrophin leads to damage to muscles during contraction that eventually results in replacement of normal muscle by fibrous tissue and fat. Duchenne muscle dystrophy is an X-linked disorder that presents clinically in boys by the age of 2 or 3 years and often results in loss of ambulation by age 10, ventilation dependency by age 20, and premature death within 5 to 20 years thereafter. In animal models of muscular dystrophy, viltolarsen resulted in skipping of exon 53 and creation of a truncated but functional dystrophin gene. In small placebo controlled trials of viltolarsen in patients with Duchenne muscular dystrophy with mutations in exon 53 amenable to correction by the drug, dystrophin protein levels increased in treated subjects and not in controls. The studies demonstrated evidence of mild clinical improvement in 6 minute walk tests after 25 weeks of therapy, which compared favorably to historical controls among whom such tests typically worsened. Longer term studies are underway to determine whether ambulation and ventilation can be maintained with continued treatment. Based upon changes in dystrophin levels and some degree of clinical improvement, viltolarsen was granted accelerated approval for use in the United States in 2020. Its indications are limited to patients with Duchenne muscular dystrophy with a confirmed mutation that is correctable by exon 53 skipping. Viltolarsen is available in solution in single dose vials of 250 mg in 5 mL (50 mg/mL). The recommended regimen is 80 mg per kg body weight once weekly by intravenous infusion. Side effects of viltolarsen are generally mild but can include injection site reactions, cough, fever, headache, symptoms of upper respiratory infection, diarrhea, arthralgia, and urticaria. Renal toxicity, which was observed in preclinical studies in animals was not found in human trials but monitoring for renal function is recommended. The weekly intravenous infusions of viltolarsen sometimes necessitate insertion of an indwelling venous access catheter, which can result in serious complications of infection, thrombosis or septicemia with long term use.

### Hepatotoxicity

Duchenne muscular dystrophy is rare affecting ~1:5000 newborn boys, and those with deletion mutants in exon 53 that would be amenable to viltolarsen therapy account for only 8% of patients with the disease. The pivotal trials of viltolarsen were conducted in rather small numbers of patients, and the full spectrum of hepatotoxicity may not be fully known. Nevertheless, serum aminotransferase elevations were not described in the registration trials of viltolarsen and there were no discontinuations for liver adverse events and no episodes of clinically apparent liver injury. Thus, viltolarsen has not been linked to instances of acute hepatitis or jaundice, but it has had limited clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why viltolarsen or other RNA antisense therapeutics for Duchenne muscular dystrophy might cause hepatic injury is unknown. One possibility is that exon skipping may cause disruption of translation of other genes in hepatocytes. Viltolarsen and other antisense molecules are largely excreted unchanged in the urine and have little effect on cytochrome P450 enzyme activities or metabolism of other drugs.

### Outcome and Management

Viltolarsen therapy has not been associated with liver injury, either in the form of minor serum enzyme elevations or clinically apparent liver injury. There is no reason to suspect cross reactivity of the hepatic injury with other antisense therapies or drugs used to treat Duchenne muscular dystrophy. Regular monitoring of liver tests during therapy is not generally recommended.

Drug Class: Genetic Disorder Agents

Other Therapeutic Antisense RNA Agents for Duchenne Muscular Dystrophy: Casimersen, Eteplirsen, Golodirsen

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Viltolarsen – Viltepso®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Viltolarsen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Viltolarsen | 2055732-84-6 | C244-H381-N113-O88-P20

## ANNOTATED BIBLIOGRAPHY

References updated: 29 November 2022

Abbreviations: siRNA, small interfering RNA; RNAi, RNA interference.

Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to siRNAs or antisense therapies or medications for muscular dystrophy).
Chi X, Gatti P, Papoian T. (2017). Safety of antisense oligonucleotide and siRNA-based therapeutics. Drug Discov Today. (Oligonucleotide and siRNA based treatments are currently being evaluated in several diseases and have been found to have unexpected toxicities including antisense thrombocytopenia [mipomersen, drisapersen] and peripheral neuropathy [revusiran]; no discussion of hepatotoxicity).
Levin AA. (2019). Treating disease at the RNA level with oligonucleotides. N Engl J Med. (Review of the mechanism of action, current status and future promise of RNA based therapies that use synthetic oligonucleotides to modulate RNA function and have been applied to diseases ranging from hemophilia, amyloidosis, muscular dystrophy and hyperlipidemia).
Messina S, Vita GL. (2018). Clinical management of Duchenne muscular dystrophy: the state of the art. Neurol Sci. (Review of current optimal clinical management of Duchenne muscular dystrophy focusing upon standard respiratory, cardiovascular, orthopedic and nutritional support as well as recent innovative approaches to therapy including exon skipping and premature stop codon suppression).
Setten RL, Rossi JJ, Han SP. (2019). The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]).
Verhaart IEC, Aartsma-Rus A. (2019). Therapeutic developments for Duchenne muscular dystrophy. Nat Rev Neurol. (Review of mechanisms of action, challenges, and clinical efficacy of new molecular approaches to therapy of muscular dystrophy including gene therapy with viral vectors, exon skipping using antisense oligonucleotides [casimersen, eteplirsen, drisapersen, golodirsen, viltolarsen], stop coding readthrough [ataluren], gene addition, CRISPR-Cas9 genome editing, and myoblast transplantation).
FDA Multi-Disciplinary Review and Evaluation. Viltolarsen. 2020. Available at: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/212154Orig1s000MedR.pdf (The FDA clinical review of viltolarsen for efficacy and safety found minor increases in dystrophin levels in muscle biopsies but no improvement in clinical measures such as 6 minute walk test distances; therapy required intravenous infusions once weekly and insertion of a venous access port, but there were no serious adverse events attributable to the medication and no hepatic related serious adverse events or discontinuations because of liver toxicity; no mention of changes in ALT levels during therapy).
Heo Y-A. (2020). Golodirsen: First approval. Drugs. (Review of the mechanism of action, history of development, clinical efficacy and safety of golodirsen shortly after its approval for use in Duchenne muscular dystrophy mentions that in the registration trial, all patients showed exon 53 skipping responses and the mean dystrophin levels from muscle biopsies increased from baseline, but that clinical improvement rates were not reported, while adverse events in treated vs control subjects included headache [41% vs 10%], fever [41% vs 14%], falls [29% vs 19%], abdominal pain [27% vs 10%], cough [27% vs 19%], and nausea [20% vs 10%], but does not mention ALT elevations or hepatotoxicity).
Dhillon S. (2020). Viltolarsen: first approval. Drugs. (Review of the structure, mechanism of action, pharmacokinetics, clinical efficacy and safety of viltolarsen a phosphorodiamidate morpholino antisense oligonucleotide that skips exon 53 of the dystrophin gene resulting in a shortened but active dystrophin molecule; adverse events are generally mild and nonspecific and there were no serious adverse events or liver related adverse events).
Clemens PR, Rao VK, Connolly AM, Harper AD, Mah JK, Smith EC, McDonald CM, et al., CINRG DNHS Investigators. (2020). Safety, tolerability, and efficacy of viltolarsen in boys with Duchenne muscular dystrophy amenable to exon 53 skipping: a phase 2 randomized clinical trial. JAMA Neurol. (Among 16 boys ages 4 to 9 years with Duchenne muscular dystrophy treated with viltolarsen in doses of 40 or 80 mg/kg weekly for 24 weeks, serum dystrophin levels and 6 minute walk tests improved and there were no treatment emergent adverse reactions requiring dose adjustment and “no changes from baseline in clinical laboratory values for blood and urine were clinically meaningful”).
(2020). Viltolarsen (Viltepso) for Duchenne muscular dystrophy. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of viltolarsen shortly after its approval for use in Duchenne muscular dystrophy in the US mentions that it was the second exon-skipping RNA antisense molecule approved for this indication and had evidence of improving the 6 minute walk test after 25 weeks of therapy; no mention of ALT elevations or hepatotoxicity).
Clemens PR, Rao VK, Connolly AM, Harper AD, Mah JK, McDonald CM, Smith EC, et al. (2022). Long-term functional efficacy and safety of viltolarsen in patients with Duchenne muscular dystrophy. J Neuromuscul Dis. (Among the 16 boys who participated in the U.S. phase II trial of viltolarsen in Duchenne muscular dystrophy, all agreed to enroll in a long term open label continuation study and were found to have stable disease without worsening of physical symptoms as occurred in a cohort of matched historical controls).
Alhamadani F, Zhang K, Parikh R, Wu H, Rasmussen TP, Bahal R, Zhong XB, Manautou JE. (2022). Adverse drug reactions and toxicity of the Food and Drug Administration-approved antisense oligonucleotide drugs. Drug Metab Dispos. (Review of the adverse side effects of oligonucleotide therapies approved in the US or Europe, including specific discussions of fomivirsen, mipomersen, nusinersen, inotersen, eteplirsen, golodirsen, viltolarsen and casimersen; hepatotoxicity has been described with use of mipomersen [now withdrawn] and inotersen but not with the agents used for Duchenne muscular dystrophy).
Roshmi RR, Yokota T. (2023). Viltolarsen: from preclinical studies to FDA approval. Methods Mol Biol. (Review of the efficacy and safety of 10 oligonucleotide therapies approved in the US or Europe, including specific discussions of fomivirsen, mipomersen, eteplirsen, nusinersen, patisiran, givosiran and golodirsen).

## OTHER REFERENCE LINKS

1 Recent References on Viltolarsen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Viltolarsen/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Viltolarsen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Viltolarsen)